# Melatonin

## OVERVIEW

### Introduction

Melatonin is a hormone produced by the pineal gland that has multiple effects including somnolence, and is believed to play a role in regulation of the sleep-wake cycle. Melatonin is available over-the-counter and is reported to have beneficial effects on wellbeing and sleep. Melatonin has not been implicated in causing serum enzyme elevations or clinically apparent liver injury.

### Background

Melatonin is a small molecular weight amine (N-actyl-5-methoxytryptamine) synthesized in the pineal gland from serotonin (5-HT). Melatonin is released into the circulation in a circadian pattern, the plasma levels being low during the day and high at night. In persons with normal sleep-wake patterns, peak melatonin values are present between 2:00 am and 4:00 am and drop before light onset in the morning. Melatonin acts by engagement of melatonin receptors (MT-1 and MT-2) causing a reduction of body temperature and alternation of brain monoamine levels, which can induce somnolence. Melatonin also has potent antioxidant activity and may have reproductive effects and modulate immune reactions. Melatonin has been proposed as therapy of sleep disturbances including insomnia and jet lag, but it has not been approved for this or any other indication in the United States. Melatonin is considered a nutritional supplement and is available over-the-counter in multiple generic forms and formulations. Melatonin is also found in many herbal and nutrition supplement mixtures. A common dose is 10 mg once daily, taken orally one to three hours before sleep time. Side effects are few but may include daytime somnolence, dizziness, headache and nausea.

### Hepatotoxicity

In several clinical trials, melatonin was found to be well tolerated and not associated with serum enzyme elevations or evidence of liver injury. Despite wide scale use, melatonin has not been convincingly linked to instances of clinically apparent liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Herbal and Dietary Supplements; Sedatives and Hypnotics

Other Drugs in the Subclass, Melatonin and its Analogues: Ramelteon, Tasimelteon

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Melatonin – Generic, In Combination

DRUG CLASS

Herbals and Dietary Supplements

Sedatives and Hypnotics

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health (https://www.nccih.nih.gov/health/melatonin-what-you-need-to-know)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Melatonin | 73-31-4 | C13-H16-N2-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 10 January 2020

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 731-4. (Expert review of hepatotoxicity published in 1999; melatonin is not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS] does not mention melatonin).
Guardiola-Lemaître B. (1997). Toxicology of melatonin. J Biol Rhythms. (Discussion of potential side effects and toxicities of melatonin, most of which relate to alteration in circadian rhythms; ALT elevations and hepatotoxicity are not mentioned).
Arendt J. (1997). Safety of melatonin in long-term use. J Biol Rhythms. (Potential long term adverse effects of melatonin include inhibition of reproductive function, delayed puberty and effects on circadian rhythm none of which have proven to be a problem).
Penev PD, Zee PC. (1997). Melatonin: a clinical perspective. Ann Neurol. (Overview of the physiology of the pineal gland, melatonin and circadian rhythms and discussion of potential uses for melatonin).
Seabra ML, Bignotto M, Pinto LR, Tufik S. (2000). Randomized, double-blind clinical trial, controlled with placebo, of the toxicology of chronic melatonin treatment. J Pineal Res. (Controlled trial of melatonin [10 mg daily] vs placebo for 28 days in 40 volunteers found no changes or abnormalities of serum bilirubin, ALT, AST or Alk P during the 4 weeks of treatment).
Buscemi N, Vandermeer B, Hooton N, Pandya R, Tjosvold L, Hartling L, Vohra S, et al. (2006). Efficacy and safety of exogenous melatonin for secondary sleep disorders and sleep disorders accompanying sleep restriction: meta-analysis. BMJ. (Systematic review of literature on efficacy and safety of melatonin for sleep disorders; in 9 randomized controlled trials there was no overall evidence of benefit; in 10 studies evaluating safety, there was no evidence of adverse effects occurring more often than with placebo with use limited to 3 months).
Erman M, Seiden D, Zammit G, Sainati S, Zhang J. (2006). An efficacy, safety, and dose-response study of Ramelteon in patients with chronic primary insomnia. Sleep Med. (Controlled crossover trial of 4 doses of ramelteon vs placebo in 107 patients with chronic primary insomnia found no difference in rate of side effects compared to placebo, the most common being headache and somnolence; serum enzymes not tested).
Devi V, Shankar PK. (2008). Ramelteon: a melatonin receptor agonist for the treatment of insomnia. J Postgrad Med. (Review of the mechanism of action, efficacy and safety of ramelteon, a melatonin receptor agonist, in treatment of insomnia).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; melatonin is not listed or discussed).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to complementary and alternative medications and herbals to the Swedish Registry; melatonin is not listed or discussed).
Mayer G, Wang-Weigand S, Roth-Schechter B, Lehmann R, Staner C, Partinen M. (2009). Efficacy and safety of 6-month nightly ramelteon administration in adults with chronic primary insomnia. Sleep. (Controlled trial of 6 month course of ramelteon vs placebo in 451 adults with primary chronic insomnia; adverse effects were similar between the two groups; no mention of ALT levels).
Wade AG, Ford I, Crawford G, McConnachie A, Nir T, Laudon M, Zisapel N. (2010). Nightly treatment of primary insomnia with prolonged release melatonin for 6 months: a randomized placebo controlled trial on age and endogenous melatonin as predictors of efficacy and safety. BMC Med. (Controlled trial of 6 months of prolonged release melatonin vs placebo in 791 adults with primary insomnia; there were no "treatment-related trends" in changes in clinical laboratory tests).
Pearl PL, Drillings IM, Conry JA. (2011). Herbs in epilepsy: evidence for efficacy, toxicity, and interactions. Semin Pediatr Neurol. (Review of herbal therapies for epilepsy including melatonin, adverse events are uncommon with melatonin and rarely require dose adjustment or discontinuation).
Garfinkel D, Zorin M, Wainstein J, Matas Z, Laudon M, Zisapel N. (2011). Efficacy and safety of prolonged-release melatonin in insomnia patients with diabetes: a randomized, double-blind, crossover study. Diabetes Metab Syndr Obes. (Controlled 3 week cross over trial of a prolonged release melatonin in 36 diabetic patients with insomnia; no serious adverse events reported and no mention of ALT levels or liver injury).
De Leersnyder H, Zisapel N, Laudon M. (2011). Prolonged-release melatonin for children with neurodevelopmental disorders. Pediatr Neurol. (Open label study of long term, prolonged release melatonin in 88 children with neurodevelopmental disorders reported no significant adverse events except for daytime somnolence).
Nickkholgh A, Schneider H, Sobirey M, Venetz WP, Hinz U. (2011). The use of high-dose melatonin in liver resection is safe: first clinical experience. J Pineal Res. (Controlled trial of single high dose of melatonin [50 mg/kg] in 50 patients undergoing major liver resection found lower ALT and AST levels during the 4 immediate postoperative days, but the differences were not statistically significant).
Lemoine P, Wade AG, Katz A, Nir T, Zisapel N. (2012). Efficacy and safety of prolonged-release melatonin for insomnia in middle-aged and elderly patients with hypertension: a combined analysis of controlled clinical trials. Integr Blood Press Control. (Review of 3 randomized controlled trials of prolonged release melatonin for insomnia in older patients with hypertension found rate of adverse events lower in treated than placebo subjects; "hepatobiliary disorders" were reported in 15 of 1834 [0.8%] patients on melatonin versus 4 of 1558 [0.2%] receiving placebo, but no details given).
Steindl PE, Finn B, Bendok B, Rothke S, Zee PC, Blei AT. (1995). Disruption of the diurnal rhythm of plasma melatonin in cirrhosis. Ann Intern Med. (Analysis of plasma melatonin levels taken every 30 minutes for 24 hours in 6 patients with cirrhosis and 6 controls found elevated levels in cirrhotic patients during the day and delayed peaks during nighttime, but no correlation of these abnormalities with sleep disturbance).
Montagnese S, Middleton B, Mani AR, Skene DJ, Morgan MY. (2010). On the origin and the consequences of circadian abnormalities in patients with cirrhosis. Am J Gastroenterol. (Analysis of plasma melatonin levels taken hourly in 20 patients with cirrhosis and 9 controls found "central circadian disruption" and delayed peak levels during nighttime, but no correlation with sleep disturbance).
Morris CJ, Aeschbach D, Scheer FA. (2012). Circadian system, sleep and endocrinology. Mol Cell Endocrinol. (Review of the biologic basis of circadian rhythm including the role of melatonin).
(2005). Ramelteon (Rozerem) for insomnia. Med Lett Drugs Ther. (Concise review of the mechanism of action, efficacy and safety of ramelteon published shortly after its approval for use in insomnia in the United States; adverse effects include somnolence, dizziness, nausea, fatigue, headache and insomnia, but no mention is made of ALT elevations or hepatotoxicity; mentions that melatonin itself is available in the US only as a "dietary supplement").
Lemoine P, Zisapel N. (2012). Prolonged-release formulation of melatonin (Circadin) for the treatment of insomnia. Expert Opin Pharmacother. (Review of the physiology of melatonin, mechanism of action, and efficacy of safety of a prolonged release formulation [Circadin] for treatment of insomnia reported no significant differences of melatonin compared with placebo in type and frequency of adverse events).
(2012). Drugs for insomnia. Treat Guidel Med Lett. (Guidelines for therapy of insomnia; mentions that melatonin has been "reported to be effective in some patients with insomnia" when taken 3-5 hours before desired time to sleep, but not when taken at bedtime; the hypnotic dose and purity of melatonin available as dietary supplements have not been established).
Andersen LP, Gögenur I, Rosenberg J, Reiter RJ. (2016). The Safety of Melatonin in Humans. Clin Drug Investig. (Review of the safety of melatonin concludes that no studies of its use have reported serious adverse events and only mild events such as dizziness, headache, nausea and somnolence arose in short term trials; no mention of ALT elevations or hepatotoxicity despite “extensive biochemical testing” in some studies).
(2018). Drugs for chronic insomnia. Med Lett Drugs Ther. (Concise review of drugs used for insomnia mentions that melatonin has been reported to be effective “in some patients”; no mention of ALT elevations or hepatotoxicity).
Maras A, Schroder CM, Malow BA, Findling RL, Breddy J, Nir T, Shahmoon S, et al. (2018). Long-term efficacy and safety of pediatric prolonged-release melatonin for insomnia in children with autism spectrum disorder. J Child Adolesc Psychopharmacol. (Among 95 children with autism treated with prolonged release melatonin [2, 5 or 10 mg] or placebo once daily for 13 weeks followed by an open label period, there were no treatment related serious adverse events and no mention of ALT elevations or hepatotoxicity).
Madsen MT, Zahid JA, Hansen CH, Grummedal O, Hansen JR, Isbrand A, Andersen UO, et al. (2019). The effect of melatonin on depressive symptoms and anxiety in patients after acute coronary syndrome: The MEDACIS randomized clinical trial. J Psychiatr Res. (Among 252 adults with acute coronary syndrome treated with melatonin [25 mg] or placebo once daily for 12 weeks, there were no differences in rates of depression or in adverse events in the two treatment groups).
Foley HM, Steel AE. (2019). Adverse events associated with oral administration of melatonin: A critical systematic review of clinical evidence. Complement Ther Med. (Systematic review of 50 randomized controlled trials found 26 articles reported no differences in rates of adverse events of melatonin compared to placebo and 24 with higher rates of minor and transient side effects with melatonin, usually drowsiness and fatigue; no mention of ALT elevations or hepatic adverse events).

## OTHER REFERENCE LINKS

1 Recent References on Melatonin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Melatonin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Melatonin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Melatonin)